# Griseofulvin

## OVERVIEW

### Introduction

Griseofulvin is a fungistatic agent used to treat superficial fungal skin infections such as tinea capitis and pedis. Griseofulvin therapy can cause transient mild-to-moderate serum aminotransferase elevations and has very rarely been linked to clinically apparent acute drug induced liver injury.

### Background

Griseofulvin (gris" ee oh ful' vin) is a metabolic product of Penicillium griseofulvum with potent activity against fungal agents. Its antifungal activity is believed to be due to disruption of the mitotic spindle of fungal cells, which interferes with cell division. Griseofulvin may also inhibit fungal DNA replication. Griseofulvin has been used for superficial dermatophyte infections (tinea corporis, capitis, barbae, cruris, pedis or unguium) for many years. Griseofulvin is available in generic forms as tablets of 500 mg, and an oral suspension in several generic forms and under the brand names of Grifulvin V and as film coated tablets of 125 and 250 mg as Gris-PEG. Because of the availability of other more potent antifungal agents with a wider sprectum of action, griseofulvin is now rarely used. The usual recommended dose is 500 to 1000 mg daily depending upon the type and severity of the infection. Common side effects include nausea, vomiting and headache.

### Hepatotoxicity

Transient mild-to-moderate elevations in serum aminotransferase levels occur in up to 5% of patients treated with griseofulvin, but these abnormalities are usually asymptomatic and resolve even with continuation of the medication. Clinically apparent hepatotoxicity is rare and only isolated case reports have been published. The liver injury is typically cholestatic and usually arises within the first few months of therapy. Signs of hypersensitivity such as fever, rash and eosinophilia are rare but griseofulvin can include hypersensitivity reactions and at least one case of DRESS syndrome accompanied by serum aminotransferase elevations has been reported with its use. Published cases of griseofulvin induced liver injury have all been self-limited, recovery requiring 1 to 3 months. Griseofulvin can increase intrahepatic levels of protoporphyrin and induce acute attacks of porphyria in patients with acute intermittent porphyria in remission.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of clinically apparent hepatotoxicity from griseofulvin is unknown, but it is extensively metabolized by the liver which may lead to production of a toxic intermediate. In high doses, griseofulvin can interfere with the mitotic spindle in mammalian cells by binding to microtubular proteins. Griseofulvin also inhibits ferrocheletase activity the enzyme that inserts iron into the prophyrin ring and, therefore, interferes with porphyrin metabolism and can trigger attacks of acute porphyria.

### Outcome and Management

The severity of the liver injury due to griseofulvin ranges from mild and transient enzyme elevations to marked cholestatic hepatitis. Typically, improvements are seen within a few weeks of discontinuation. Rechallenge may lead to recurrence and should be avoided. No cases of acute liver failure or chronic bile duct injury have been reported due to griseofulvin. There is no evidence for cross sensivity to hepatic injury between griseofulvin and other antifungal agents.

Drug Class: Antifungal Agents

## CASE REPORT

### Case 1. Griseofulvin induced hepatitis.

[Modified from: Chiprut RD, Viteri A, Jamroz C, Dyck WP. Intrahepatic cholestasis after griseofulvin administration. Gastroenterology 1976; 70: 1141-3. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/131731)]

A 63 year old man developed anorexia, fatigue and pruritus 3 weeks after restarting griseofulvin (500 mg twice daily), but didn’t stop treatment until ten days later when he was admitted for evaluation. He was jaundiced but without rash or fever. Laboratory results showed elevations in bilirubin, AST and alkaline phosphatase (Table). Liver tests had been normal in the past, including five months previously when he had a hypersensitivity reaction to griseofulvin (which he had been taking for 5 months and was then stopped for several weeks and then restarted). In addition, he underwent bilateral renal artery endartectomy for severe hypertension and required several blood transfusions approximately 2 months before presentation with jaundice. He did not drink alcohol and took no other medications. Testing showed absence of HBsAg and autoantibodies. A liver biopsy showed intrahepatic cholestasis that was interpreted as compatible with drug induced liver injury. After stopping griseofulvin, he rapidly became asymptomatic and all liver tests were normal three months later.

#### Key Points

Medication: | Griseofulvin
Pattern: | Cholestatic (R=0.7)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 3 weeks (reexposure) to symptoms, 5 weeks to jaundice
Recovery: | Within 3 months
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | 0 | 46 | 24 | 0.9 | Surgery
5 weeks | 0 | 75 | 43 | 3.4 | Admission
6 weeks | 1 week | 26 | 35 | 2.4 | Liver biopsy
10 weeks | 5 weeks | 54 | 32 | 1.1
4.5 months | 3 months | 30 | 17 | 0.7
~1 year | ~1 year | 30 | 15 | 0.8
Normal Values | | <40 | <13 | <1.2

#### Comment

This patient developed a mild cholestatic hepatitis 3 weeks after restarting griseofulvin, having a previous history compatible with a drug-hypersensitivity reaction (facial edema and pruritus). A liver biopsy was compatible with drug induced cholestasis as was the improvement that followed discontinuation. Because he received a blood transfusion approximately 2 months before developing symptoms of liver injury, the possibility of hepatitis C (which had yet to be described in 1976) also exists, but the pattern of enzyme elevation and liver biopsy were not typical of viral hepatitis. Despite griseofulvin’s known effects on the liver in mice and rats (causing Mallory body formulation), there have been very few case reports of liver injury due to griseofulvin published in the literature.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Griseofulvin – Generic, Grifulvin V®

DRUG CLASS

Antifungal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=griseofulvin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Griseofulvin | 126-07-8 | C17-H17-Cl-O6 | Image of Griseofulvin Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 14 March 2018

Zimmerman HJ. Antifungal agents. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents published in 1999 mentions that griseofulvin is an interesting experimental hepatoxin [causing Mallory body formation in rats], but produces little hepatic injury in humans).
Moseley RH. Antifungal agents. Hepatoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 470-3. (Review of hepatotoxicity of antifungal agents mentions that griseofulvin causes a variety of acute and chronic effects in rodents, but hepatotoxicity is rare in humans; individual case reports have been published of cholestatic jaundice and precipitation of acute intermittent porphyria).
Bennett JE. Antifungal agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1571-92. (Textbook of pharmacology and therapeutics; griseofulvin is fungistatic against several species of dermatophytes, but has no effect on bacteria or other fungi).
Osment LS. The many effects of griseofulvin. Ala J Med Sci 1969; 6: 392-8. (Review of griseofulvin structure, mechanism of action, efficacy and safety; griseofulvin is fungistatic, it induces hepatic microsomal enzymes and can trigger acute attacks of porphyria in susceptible patients, common side effects are gastrointestinal upset, headache and rash; it rarely causes liver injury). 4903304
Redeker AG, Sterling RE, Bronow RS. Effect of griseofulvin in acute intermittent porphyria. JAMA 1964; 188: 466-8. (Two patients with acute intermittent porphyria were given griseofulvin [1 g/day]; urine pyrole excretion increased within 2-5 days and one developed severe abdominal and leg pain, tachycardia and hypertension with elevation of ALT from 38 to 129 U/L). 14125225
Berman A, Franklin RL. Precipitation of acute intermittent porphyria by griseofulvin therapy. JAMA 1968; 192: 1005-7. (43 year old woman developed attack of acute porphyria [abdominal pain, nausea and restlessness] 7 days after starting griseofulvin [500 mg/day], with bilirubin 0.7 mg/dL, ALT 29 U/L, Alk P normal, and urine porphobilinogen positive). 14290427
Brienstrup H, Sogaard-Andersen J. Intrahepatic cholestasis after griseofulvin treatment. Ugeskr Laeger 1966; 128: 145-6. Danish. (14 year old boy developed jaundice 4 months after starting griseofulvin [bilirubin 6.1 mg/dL, ALT 312 U/L, Alk P ~3 times ULN], with recovery over next few months). 5914466
Chiprut RD, Viteri A, Jamroz C, Dyck WP. Intrahepatic cholestasis after griseofulvin administration. Gastroenterology 1976; 70: 1141-3. (63 year old man developed fatigue and pruritus 3 weeks after starting griseofulvin [bilirubin 3.4 mg/dL, AST 75 U/L and Alk P ~3 times ULN], resolving within few months of stopping: Case 1). 131731
Gotz H, Reichenberger M. Ergebnisse einer Fragebogenaktion bei 1670 Dermatologen der Bundes-Republik Deutschland uber Nebenwirkungen dei der Griseofulvintherapie. [Results of questionnaires of 1670 dermatologists in West Germany concerning the side effects of griseofulvin therapy]. Hautarzt 1975; 11: 485-92. (1670 German dermatologists answered a questionnaire regarding griseofulvin; only 5% reported having seen liver injury during therapy, the majority of which was serum aminotransferase elevations without jaundice or symptoms). 4655974
Smith AG, De Matteis F. Drugs and the hepatic porphyrias. Clin Haematol 1980; 9: 399-425. (Extensive review of the effects of drugs on heme metabolism and porphyria; griseofulvin appears to inhibit hepatic ferrochelatase, leading to accumulation of protoporphyrin). 7398153
Simon N, Berko G, Polay A, Kocsis G. Der Einflus der Griseofulvintherapie auf die Leber function und den Porphyrin-Stofwechsel. [Influence of griseofulvin treatment on liver function and porphyrine metabolism]. Arch Dermatol Forsch 1981; 241: 148-55. (Griseofulvin therapy in humans leads to transient increase in serum AST and erythrocyte porphyrin levels, but this effect is highly variable and abnormalities usually return to normal within a few weeks). 4255210
Hay RJ, Clayton YM, Griffiths WA, Dowd PM. A comparative double blind study of ketoconazole and griseofulvin in dermatophytosis. Br J Dermatol 1985; 112: 691-6. (Controlled trial of ketoconazole vs griseofulvin for up to one year in 74 patients with dermatophytoses; similar efficacy; side effects were mild and there was no evidence of liver toxicity in either group “as assessed clinically or by liver function tests.”). 3890924
Lambert DR, Siegle RJ, Camisa C. Griseofulvin and ketoconazole in the treatment of dermatophyte infections. Int J Dermatol 1989; 28: 300-4. (Review of efficacy and safety of griseofulvin and ketoconazole for superficial mycoses; rate of hepatotoxicity of ketoconazole ranges from 1:10,000 to 1:15,000, and is more common among women and in persons over 40 years of age; recommends routine monitoring of liver enzymes; in contrast, griseofulvin is “remarkably safe” and no deaths have been attributed directly to the drug). 2666321
Hay RJ. Risk/benefit ratio of modern antifungal therapy: focus on hepatic reactions. J Am Acad Dermatol 1993; 29: S50-4. (Review article on hepatotoxicity of antifungal agents, griseofulvin, ketoconazole, fluconazole, itraconazole and terbinafine; does not recommend routine monitoring, but stresses need to discontinue agent for hepatic injury with symptoms). 8315062
Watanabe M, Akagi S, Kohge N, Uchida Y, Jguyen TX, Hirakawa K, Fukumoto S. Laparoscopy of griseofulvin-induced liver injury presenting a wide depression. Endoscopy 1994; 26: 514-5. (42 year old man developed abnormal liver tests 4 months after starting griseofulvin [bilirubin 1.2 mg/dL, ALT 170 rising to 369 U/L despite stopping alcoholic intake]; liver biopsy showed mild inflammation without fibrosis, abnormalities resolved with stopping griseofulvin). 7956975
Polo CF, Buzalh AM, Vazquez ES, Afonso SG, Navone NM, del Carmen Battle AM. Griseofulvin-induced hepatopathy due to abnormalities in heme pathway. Gen Pharmac 1997; 29: 207-10. (In mice, griseofulvin inhibits ferrocheletase which is responsible for inserting iron into the protoporphyrin ring and can induce attacks of protoporphyria). 9251900
Wingfield AB, Fernandez-Obregon AC, Wignall FS, Greer DL. Treatment of tinea imbricate: a randomized clinical trial using griseofulvin, terbinafine, itraconazole and fluconazole. Br J Dermatol 2004; 150: 119-26. (Randomized trial of four antifungals for 4 weeks for tinea imbricate in 86 patients in New Guinea; griseofulvin and terbinafine were effective; itraconazole and fluconazole were not; only one patient had ALT elevation [3-fold: terbinafine]). 14746625
Song J, Deresinski S. Hepatotoxicity of antifungal agents. Curr Opin Investig Drugs 2005; 6: 170-7. (Extensive review of hepatotoxicity of antifungal agents; although griseofulvin is rarely associated with hepatotoxicity, it has been linked to rare cases of cholestatic hepatitis arising after 1-4 months of therapy). 15751740
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 8 cases were attributed to antifungal agents, but no cases were attributed to griseofulvin). 18955056
Elewski BE, Cáceres HW, DeLeon L, El Shimy S, Hunter JA, Korotkiy N, Rachesky IJ, et al. Terbinafine hydrochloride oral granules versus oral griseofulvin suspension in children with tinea capitis: results of two randomized, investigator-blinded, multicenter, international, controlled trials. J Am Acad Dermatol 2008; 59: 41-54. (Controlled trial of 6 weeks of terbinafine vs griseofulvin in 1549 children with tinea capitis; side effects were similar; low rate of serum biochemistry abnormalities, although 2 patients on griseofulvin stopped therapy because of serum aminotransferase elevations). 18378354
Kao WY, Su CW, Huang YS, Chou YC, Chen YC, Chung WH, Hou MC, et al. Risk of oral anti-fungal agent-induced liver injury in Taiwanese. Br J Clin Pharmacol 2014; 77: 180-9. (Analysis of Taiwan national health Insurance database from 2002-2008 identified 52 patients with drug induced liver injury among 90,847 users of oral antifungal agents, rates were were 4.3 per 10,000 persons taking griseofulvin [8 cases], but none were fatal). 23750489
Raschi E, Poluzzi E, Koci A, Caraceni P, Ponti FD. Assessing liver injury associated with antimycotics: Concise literature review and clues from data mining of the FAERS database. World J Hepatol 2014; 6: 601-12. (Analysis of spontaneous reports of drug induced liver injury to the FDA between 2004 and 2011 identified 1964 cases attributed to antifungal agents, only 3 of which were linked to griseofulvin, none of which were fatal). 25232453
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 14 cases [1.6%] were attributed to antifungal agents including 7 due to terbinafine, 6 triazoles [4 fluconazole, 1 ketoconazole and 1 voriconazole], 1 micafungin, but none due to griseofulvin). 25754159
Smith RJ, Boos MD, McMahon P. Probable griseofulvin-induced drug reaction with eosinophilia and systemic symptoms in a child. Pediatr Dermatol 2016; 33: e290-1. (9 year old boy developed fever, rash, adenopathy and liver test abnormalities 3 weeks after starting griseofulvin [bilirubin not provided, ALT 31 rising to 282 U/L, Alk P 170 rising to 285 U/L, eosinophils 310/µ L], rash, fever and laboratory abnormalities resolving within 2-4 weeks of starting prednisone therapy). 27397873
Kyriakidis I, Tragiannidis A, Munchen S, Groll AH. Clinical hepatotoxicity associated with antifungal agents. Expert Opin Drug Saf 2017; 16: 149-65. (Review of the hepatotoxicity of antifungal agents states that all antifungal agents may cause hepatic toxicity, mentions that griseofulvin has been linked to rare cases of transient liver injury, but not to acute liver failure). 27927037

## OTHER REFERENCE LINKS

1. Recent References on Griseofulvin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(griseofulvin)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Griseofulvin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=griseofulvin)